# Amphetamines

## OVERVIEW

### Introduction

The amphetamines are indirect acting sympathomimetic amines and powerful central nervous system stimulants which are used in the therapy of attention deficit disorder, hyperactivity and narcolepsy. Amphetamines also have a potential for abuse and illicit forms of amphetamines constitute some of the most dangerous, but widely used drugs of abuse. High doses of amphetamines can be associated with liver injury and distinctive forms of clinically apparent liver injury which has been most commonly associated with methylenedioxymethamphetamine (MDMA: “ecstasy”).

### Background

The amphetamines (am fet' a meens) are potent central nervous system (CNS) stimulants that are believed to act by causing release of norepinephrine at CNS nerve terminals promoting neurotransmission. Oral therapy with amphetamine has been shown to increase cognitive abilities and improve psychological functioning and performance in children and adults with suspected attention deficit disorders. The amphetamines often have a paradoxical calming action in children with hyperactivity. Amphetamines are also used in the therapy of narcolepsy and formerly for the treatment of obesity. Several forms of amphetamine have been approved for use in the United States. Amphetamine is available in multiple forms for oral administration including capsules, tablets, oral solutions, and as extended-release and long-acting forms in concentrations varying from 2.5 to 54 mg in generic forms and under several brand names, including Adderall (dextroamphetamine and amphetamine), Dexedrine (dextroamphetamine), Vyvanse (lisdexamfetamine), Desoxyn (methamphetamine), and Benzedrine (amphetamine). Transdermal formulations are also available. The usual dose in adults is 10 mg two or three times daily and average maintenance dosage is 40 to 60 mg daily. The dosage in children varies by formulation. Amphetamine is a controlled substance (Schedule II) and has major abuse potential. Common side effects include headache, insomnia, irritability, elation, agitation, confusion, palpitations, tachycardia, nasal stuffiness, and decreased appetite.

### Hepatotoxicity

In clinical trials, amphetamine has not been associated with serum aminotransferase elevations during therapy, but monitoring of serum enzymes during large scale, long term trials of therapy have not been reported.

More importantly, several amphetamines have been associated with clinically apparent and sometimes severe or even fatal instances of acute liver injury. These cases typically follow intravenous use, particularly when given in an excessive single dose. The synthetic amphetamine methylenedioxymethamphetamine (MDMA, but known familiarly as “ecstasy”) has been implicated in the largest number of cases, many of which were severe and led to acute liver failure and death. The onset of ecstasy associated hepatitis is generally 3 to 14 days after ingestion and the onset is typically abrupt with fatigue, weakness, jaundice and confusion. The pattern of serum enzyme elevations is typically hepatocellular and ALT and AST values may be markedly increased with similar increases in lactic dehydrogenase. Onset of symptoms within a day of exposure is most frequent with acute liver failure and prolongation of the prothrombin time and other organ injury often present (renal, cardiac, muscle) (Case 1). The clinical course and early histological features of ecstasy induced hepatitis are similar to the patterns that occur with ischemic hepatitis and liver injury due to hyperthermia. Other amphetamines (such as the "designer" amphetamine, methylone or "Explosion") can cause a similar pattern of hepatic injury, but usually only when given as an overdose.

A second pattern of clinically apparent liver injury linked to amphetamines is more acute viral hepatitis-like, presenting with onset of fatigue, nausea and jaundice 1 to 2 weeks after an exposure or daily use (Case 2). These cases also can be severe, but are usually self-limiting. Immunoallergic features are uncommon and autoantibodies are usually not present. Recovery occurs with 1 to 3 months. Recurrence on reexposure has not been reported. However, a difficulty with analysis of cases of amphetamine induced liver injury is that the agent is often used illegally and patients are usually unwilling to return for long-term follow up (Cases 1 and 2).

Likelihood score: A[HD] (well established cause of liver injury, but severe cases occur only with high doses).

### Mechanism of Injury

The mechanism by which the amphetamines cause liver injury is unknown, but amphetamines undergo extensive hepatic metabolism largely by the hepatic P450 system (CYP 2D6) and generation of a toxic metabolite may be the cause of hepatic injury with high doses of amphetamines. In cases of hyperacute liver failure due to ecstasy and to intravenous amphetamine, hyperthermia, shock and ischemia may account for the early liver injury.

### Outcome and Management

The liver injury due to the amphetamines is usually self-limited and resolves rapidly. However, the acute liver injury can be severe and may require emergency liver transplantation within days of presentation. Several cases of chronic hepatitis apparently due to ecstasy have been described, usually in patients who continue to abuse MDMA. In these cases, liver biopsy shows features of chronic hepatitis with fibrosis, but cirrhosis has yet to be described and the co-occurrence of chronic hepatitis C among drug users may complicate the clinical picture. Patients with ecstasy induced hepatitis should be cautioned against its continued use, but the frequency of recurrence upon rechallenge is unclear. As with other amphetamines, the liver injury appears to be partially dose related.

Central nervous system stimulants used for attention deficit disorder, narcolepsy or excessive sleepiness include methylphenidate, atomoxetine, modafinil, armodafinil and the amphetamines. Stimulants that are no longer used for medical conditions but that are abused include cocaine and ecstasy or methylenedioxymethamphetamine.

Drug Class: Central Nervous System Stimulants

## CASE REPORTS

### Case 1. Acute hepatic necrosis after methylenedioxymethamphetamine (Ecstasy) use.(1)

A 32 year old woman developed hallucinations and confusion a few hours after ingesting 100 to 150 mg of methylenedioxymethamphetamine (MDMA) and was brought to the emergency room with agitation, disorientation and high fever. On examination, she had tachycardia (150/min), hypotension (90/50 mm Hg), tachypnea (36/min) and fever (41.6 ^o^C). She had dilated pupils, nystagmus and hyperreflexia. Laboratory tests showed normal blood counts and liver tests with mild dehydration (creatinine 1.9 mg/dL), and serious hypoxemia (pO2 44 mm). She was admitted to an intensive care unit for ventilator support for 24 hours. Thereafter, she had weakness, anorexia and nausea, but improved over the next week and was discharged 10 days after admission. She had no previous history of liver disease or jaundice and took no other medications. She had used MDMA previously without complications. She denied injection drug use. During the course of her hospitalization, she developed elevations in serum enzymes and jaundice (Table). The prothrombin time became abnormal, but she remained stable and liver test abnormalities were markedly improved over the 10 day hospitalization. Analysis of the recovered powder that was taken demonstrated that it was 99% pure MDMA.

#### Key Points

Medication: | Methylenedioxymethamphetamine (MDMA: “Ecstasy”)
Pattern: | Hepatocellular (R=~100)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 3 days to jaundice
Recovery: | Rapid, not completely documented
Other medications: | None mentioned

#### Laboratory Values

Time After Stopping | AST (U/L) | Alk P (U/L) | INR | Bilirubin* (mg/dL) | Other
| Single Ingestion of MDMA
0 | 30 | 50 | 13.6 | 0.4 | Admission
1 day | 385 | 65 | 33.2 | 1.2 | Extubation
2 days | | | 37.9
3 days | 1820 | 107 | 18.9 | 6.8
4 days | 1435 | 90 | 13.8 | 7.6
5 days | 1680 | 145 | 12.8 | 5.6
10 days | 237 | 68 | | 1.6 | Discharge
Normal | <42 | <115 | <14.5 | <1.2

#### Comment

Abuse of MDMA, an amphetamine derivative used orally as a “social” drug, often during “rave” parties, has been associated with severe toxic reactions with severe hyperthermia, shock, respiratory failure and hepatitis. This case demonstrates the timing of the “hyperacute” hepatic failure that can occur with MDMA use, with early and immediate presentation and with the acute adverse effects of amphetamines (sympathomimetic reactions of tachycardia, papillary dilation and confusion). The liver injury arises 1 to 3 days later, the prothrombin time becoming abnormal immediately followed by rise in ALT and AST and jaundice. The clinical pattern is “acute hepatic necrosis” as occurs with toxic reactions, most typically with acetaminophen overdose. The cause of the hyperacute hepatic failure due to MDMA may actually be hyperthermia as the early hepatic histology resembles hyperthermia induced liver injury (fat accumulation and central coagulative necrosis). Why a person who has been regularly abusing MDMA should suddenly have such an overwhelming toxic reaction is unclear, but it probably represents drug overdose and administration of more than claimed dose of the illegally (and unreliably) prepared substance, or else an underlying change in susceptibility (perhaps dehydration from participation in a “rave” or a concurrent illness). Differing slightly from this acute toxic hepatitis are cases of a more protracted course of an acute viral hepatitis-like outcome from MDMA use that typically have a longer latency and longer course (Case 2). Cases of liver injury due to amphetamine have resembled this toxic course and have usually arisen after an acute overdose, usually from intravenous amphetamine use.

### Case 2. Acute hepatitis after methylenedioxymethamphetamine (Ecstasy) use.(2)

A 17 year old male who had been taking MDMA on weekends for 2 to 3 months developed fatigue followed by dark urine and jaundice. He had no previous history of liver disease or jaundice and took no other medications. He denied injection drug use. On examination, he was jaundiced but had no rash or fever. Laboratory testing showed elevations in serum bilirubin (5.6 mg/dL) and aminotransferase levels (Table). His prothrombin index was 58%. Tests for hepatitis A, B and C and for Epstein-Barr virus infection were negative as were autoantibodies. A liver biopsy showed acute hepatitis with occasional giant hepatocytes. His serum bilirubin continued to rise for the next 4 weeks, peaking at 28.1 mg/dL. Thereafter, he improved and all liver tests were normal 4 months later.

#### Key Points

Medication: | Methylenedioxymethamphetamine (MDMA: “Ecstasy”)
Pattern: | Hepatocellular (R=~5.5)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 2 weeks to jaundice
Recovery: | Slow, almost complete by 4 months
Other medications: | None

#### Laboratory Values

Time After Stopping | ALT* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
2 days | 1118 | | 5.6 | Prothrombin index 58%
4 days | 750 | 280 | 21.6
5 days | 320 | 280 | 20.5
7 days | 1090 | 480 | 27.8
8 days | 850 | 240 | 22.2
10 days | 800 | | 21.6 | Liver biopsy: giant cells
11 days | 750 | | 8.7
13 days | 300 | 240 | 3.2
17 days | 50 | 200 | 2.4
3 weeks | 50 | 200 | 2.4
Normal | <65 | <136 | <1.2

* Estimated from Figure 3.

#### Comment

Abuse of MDMA is frequently not mentioned by the patient, but should be considered in any young person with an unexplained acute hepatitis. This patient had an acute viral hepatitis-like presentation with a prolonged course starting a few weeks after last taking MDMA. There was no history of an acute episode of agitation, hypotension and hyperthermia and the pattern of liver enzyme elevations was more typical of hepatitis, remaining elevated for several weeks. The finding of giant cells on liver biopsy is largely nonspecific and does not help with the diagnosis.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Amphetamine – Generic, Benzedrine®

DRUG CLASS

Central Nervous System Stimulants

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Amphetamine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Amphetamine | 300-62-9 | C9-H13-N

## CITED REFERENCES

1 Brown C, Osterloh J. (1987). Multiple severe complications from recreational ingestion of MDMA ('Ecstasy'). JAMA.
2 Muñoz P, Drobinska A, Bianchi L, Züger C, Pirovino M. [Acute giant cell hepatitis in a 17-year old man]. Praxis (Bern 1994) 2004; 93: 2109-12. German.

## ANNOTATED BIBLIOGRAPHY

References updated: 25 August 2021

Abbreviations: MDEA (Eve), methylenedioxyethylamphetamine; MDMA (Ecstasy), methylenedioxymethamphetamine.

Zimmerman HJ. Amphetamines. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 711. (Expert review of hepatotoxicity published in 1999; many instances of acute hepatitis from amphetamine use [“hippie hepatitis”] have been published; “the amphetamine most involved in hepatic injury goes by the street name of ‘ecstasy’”).
Larrey D, Ripault MP. Illegal and recretational compounts. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 456-7. (Review of hepatotoxicity of amphetamine and their derivatives mentions that the liver injury may be mostly due to hyperthermia).
Westfall TC, Macarthur H, Westfall DP. Adrenergic agonists and antagonists. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 191-224. (Textbook of pharmacology and therapeutics).
Harvey JK, Todd CW, Howard JW. (1949). Fatality associated with benzedrine ingestion; a case report. Del Med J. (35 year old man developed confusion and hallucinations a few hours after taking 250 mg of amphetamine with alcohol and 3 days later developed jaundice, agitation, fever [104oF] followed by circulatory collapse: autopsy showed centrilobular fat and hepatic necrosis).
Ginsberg MD, Hertzmann M, Schmidt-Nowara WW. (1970). Amphetamine intoxication with coagulopathy, hyperthermia and reversible renal failure. Ann Intern Med. (21 year old man took 2.2 g of amphetamine and developed agitation, delirium and fever to 108^o^F with subsequent coagulopathy, delirium and acute renal failure, but eventual recovery).
Gastpar M, Ladewig D, Richter R, Weidmann M. (1974). Schweiz Med Wochenschr. (Study of 61 drug abusing youths in Basel, Switzerland; a history of jaundice or hepatitis was frequent, but not associated with a specific drug; 97% were taking amphetamines).
Rubel LR, Ishak KG. (1983). The liver in fatal exertional heatstroke. Liver. (Liver histology of 50 cases of fatal heatstroke arising during military training in 17 to 36 year old’s; initially fatty change, vacuolization and congestion followed by zone 3 coagulative necrosis, cholestasis and microvacuolar fatty change).
Dowling GP, McDonough ET, Bost RO. (1987). 'Eve' and 'Ecstasy'. A report of five deaths associated with the use of MDEA and MDMA. JAMA. (5 deaths due to acute toxicity of MDMA and MDEA ingestion, usually sudden death within hours of ingestion, cardiovascular collapse or suicide).
Brown C, Osterloh J. (1987). Multiple severe complications from recreational ingestion of MDMA ('Ecstasy'). JAMA. (32 year old woman took 100-150 mg of MDMA and developed hallucinations, temperature to 41.6^o^C with subsequent jaundice [bilirubin peak 7.6 mg/dL on day 4, ALT 214 U/L, AST 1820 U/L, LDH 1225 U/L, Alk P 145 U/L], rhabdomyolysis, thrombocytopenia but rapid resolution [~1 week]: Case 1).
Fahal IH, Sallomi DF, Yaqoob M, Bell GM. (1992). Acute renal failure after ecstasy. BMJ. (23 year old man took MDMA during rave party and presented with hyperthermia [40^o^C], jaundice [bilirubin 4.5 mg/dL, ALT 289 U/L] and renal failure, with slow recovery).
Henry JA, Jeffreys KJ, Dawling S. (1992). Toxicity and deaths from 3,4-methylene-dioxymethamphetamine ("ecstasy"). Lancet. (Review of poison reports between 1990-92 from Guy's Hospital, London found 7 fatal cases of MDMA toxicity, 5 men and 2 women, ages 16 to 21 years, presenting with temperature >40^o^C, hypotension, cyanosis and death in 2 to 60 hours due to cardiac toxicity, rhabdomyolysis and toxic hepatitis [7 cases of liver injury with one death]).
Randall T. (1992). Ecstasy-fueled 'rave' parties become dances of death for English youths. JAMA. (News report on ecstasy toxicity and rave parties from the UK).
Henry JA. (1992). Ecstasy and the dance of death. Severe reactions are unpredictable. BMJ. (Editorial on problem of use of ecstasy in rave parties and subsequent complications).
Shearman JD, Chapman RW, Satsangi J, Ryley NG, Weatherhead S. (1992). Misuse of ecstasy. BMJ. (Letter in response to editorial by Henry [1992]; 27 year old woman with recurrent jaundice arising 8-15 days after taking MDMA [bilirubin 27.5 mg/dL, AST 1717 U/L, Alk P 439 U/L], biopsy showing florid hepatitis).
Gorard DA, Davies SE, Clark ML. (1992). Misuse of ecstasy. BMJ. (Letter in response to editorial by Henry [1992]; 20 year old man developed jaundice 20 days after taking MDMA [bilirubin 7.7 mg/dL, AST 2050 U/L, Alk P 201 U/L], resolving within 4 weeks).
Ijzermans JN, Tilanus HW, De Man RA, Metselaar HJ. (1993). "Ecstasy" and liver transplantation. Ann Med Interne (Paris). (3 cases: ages 24, 18 and 21 years; two cases with onset of jaundice after 4 and 6 months of intermittent use and one after initial use of ecstasy [bilirubin 26.0, 28.0 and 1.0 mg/dL, ALT 540, 1360 and 1100 U/L, protime 36%, 15% and 38%], one requiring liver transplantation, one with delayed and one with rapid recovery).
de Man RA, Wilson JH, Tjen HS. (1993). Ned Tijdschr Geneeskd. (18 year old woman developed acute liver failure having used ecstasy on weekends for several months [bilirubin 28.2 mg/dL, ALT 1360 U/L, Alk P 30 U/L, protime 36%], recovering spontaneously over the ensuing 2 months).
de Man RA. (1994). Ned Tijdschr Geneeskd.
Oranje WA, von Pol P. (1994). vd Wurff A, Zeijen RN, Stockbrügger RW, Arends JW. XTC-induced hepatitis. Neth J Med. (25 year old woman developed fatigue and jaundice 1-2 weeks after her last use of MDMA [referred to as XTC] having used it on weekends for 2 months [bilirubin 19.2 mg/dL, ALT 1157 U/L, Alk P normal], biopsy showing an acute hepatitis).
Jones AL, Jarvie DR, McDermid G, Proudfoot AT. (1994). Hepatocellular damage following amphetamine intoxication. J Toxicol Clin Toxicol. (Two cases; 21 year old man developed confusion, seizures and fever [41^o^C] 6 hours after amphetamine ingestion with subsequent jaundice [7.3 mg/dL, ALT 8371 U/L, Alk P 101 U/L on day 3], resolving over next 2 weeks; 18 year old woman fainted during a rave party and ecstasy use with fever [42^o^C] tachycardia and hypoxemia and subsequent jaundice [bilirubin 3.0 mg/dL, ALT 1240, Alk P 137 on day 4], resolving rapidly).
Deltenre P, Henrion J, Jacques JM, Schapira M, Ghilain JM, Maisin JM, Heller FR. (1994). Acta Gastroenterol Belg. (22 year old man taking ecstasy for at least 6 months developed jaundice [bilirubin 13.8 mg/dL, ALT 3390 U/L, Alk P 266 U/L], which resolved within 2 months of stopping).
Huarte Muniesa MP, Pueyo Royo AM. (1995). Rev Esp Enferm Dig. (23 year old male sporadic user of ecstasy developed jaundice [bilirubin 10.6 mg/dL, ALT 700 U/L, Alk P 304 U/L], resolving in 6 weeks).
Dykhuizen RS, Brunt PW, Atkinson P, Simpson JG, Smith CC. (1995). Ecstasy induced hepatitis mimicking viral hepatitis. Gut. (3 cases: 24 year old man with diabetes developed jaundice 3 days after having a beer spiked with MDMA [peak bilirubin 20.2 mg/dL, AST 950 U/L, Alk P 251 U/L], resolving over next 1-4 months; 22 year old man developed lethargy followed by jaundice 2-3 weeks after taking MDMA [peak bilirubin 21.7 mg/dL, AST 1410 U/L, Alk P 223 U/L] given short course of prednisolone, resolving in next 3 months; 23 year old man developed jaundice during intermittent use of MDMA [peak bilirubin 4.4 mg/dL, AST 639 U/L, Alk P 265 U/L], resolving over next 5 weeks).
Khakoo SI, Coles CJ, Armstrong JS, Barry RE. (1995). Hepatotoxicity and accelerated fibrosis following 3,4-methylenedioxymetamphetamine ("ecstasy") usage. J Clin Gastroenterol. (22 year old woman developed jaundice 3 months after starting weekly MDMA abuse [bilirubin 3.1 mg/dL, AST 2314 U/L, Alk P 145 U/L, protime 16.6 seconds]; continued intermittent ecstasy use and 6 months later developed ascites and worsening jaundice [bilirubin 23.9 mg/dL, AST 2214 U/L, Alk P 253 U/L protime 24.1 seconds], biopsy showed fibrosis; partial response to prednisone).
Fidler H, Dhillon A, Gertner D, Burroughs A. (1996). Chronic ecstasy (3,4-methylenedioxymetamphetamine) abuse: a recurrent and unpredictable cause of severe acute hepatitis. J Hepatol. (Two cases of acute hepatitis after MDMA, 19 year old man and 18 year old woman developed jaundice 3 and 5 months after starting MDMA use [bilirubin 7.7 and 5.6 mg/dL, ALT 745 AND 2435 U/L, Alk P 180 and 176 U/L], recurring in both after 2 months of restarting abuse, one patient had chronic liver enzyme elevations using chronic use).
Milroy CM, Clark JC, Forrest AR. (1996). Pathology of deaths associated with "ecstasy" and "eve" misuse. J Clin Pathol. (Autopsy results on 7 deaths from MDMA or MDEA use, all with zone 3 necrosis with acute inflammation surrounding it and fatty change; similar to hyperthermia).
Ellis AJ, Wendon JA, Portmann B, Williams R. (1996). Acute liver damage and ecstasy ingestion. Gut. (Three patterns of liver injury in 8 patients after ecstasy use; first, acute toxicity with hyperthermia and collapse marked by hyperacute liver failure, histology showing microvesicular fat and small areas of collapse; second, typical acute liver failure arising 1-3 weeks after last use of MDMA, histology showing submassive necrosis; third, severe acute hepatitis like syndrome arising using long term use of MDMA with recovery in 2-3 months, histology showing marked inflammation and spotty necrosis).
Chenard-Neu MP, Boudjema K, Bernuau J, Degott C, Belghiti J, Cherqui D, Costes V, et al. (1996). Auxiliary liver transplantation: regeneration of the native liver and outcome in 30 patients with fulminant hepatic failure – a multicenter European Study. Hepatology. (Combined experience with 50 auxiliary liver transplants for acute liver failure from 12 European centers; 2 cases were attributed to ecstasy, both survived and had partial regeneration and fibrosis in the native liver).
Pereira SP, McCarthy M, Ellis AJ, Wendon J, Portmann B, Rela M, Heaton N, et al. (1997). Auxiliary partial orthotopic liver transplantation for acute liver failure. J Hepatol. (Experience with auxiliary partial liver transplants in 7 patients with acute liver failure; 3 patients died early due to sepsis [including single case due to ecstasy]; native liver regenerated in 2 of 3 surviving patients).
Brauer RB, Heidecke CD, Nathrath W, Beckurts KT, Vorwald P, Zilker TR, Schweigart U, et al. (1997). Liver transplantation for the treatment of fulminant hepatic failure induced by the ingestion of Ecstasy. Transpl Int. (18 year old female who had used ecstasy over a two month period develop lethargy, nausea and jaundice [bilirubin 15.4 mg/dL, ALT 1530 U/L] and progressed to acute liver failure, underwent successful liver transplant 10 days later, graft showing submassive necrosis).
Hellinger A, Rauen U, de Groot H, Erhard J. (1997). Dtsch Med Wochenschr. (18 year old female developed jaundice 8 days after taking ecstasy, after 8 months of abuse [bilirubin 7.3 mg/dL, ALT 1460 U/L, protime 47%], with progressive hepatic failure and successful auxiliary liver transplant 26 days later).
Pascual Bartolomé S, Sarrión Martínez JV, García Herola A, Berenguer Lapuerta J. (1997). Med Clin (Barc). (17 year old developed jaundice without fever, after several months of ecstasy use on weekends [bilirubin 18.7 mg/dL, ALT 1485 U/L, Alk P 150 U/L], treated with prednisone and recovered within 2 months).
Tillmann HL, van Pelt FN, Martz W, Luecke T, Welp H, Dörries F, Veuskens A, et al. (1997). Accidental intoxication with methylene dianiline p,p'-diaminodiphenylmethane: acute liver damage after presumed ecstasy consumption. J Toxicol Clin Toxicol. (Six patients took chemical agent that caused Epping jaundice thinking that it was MDMA, and all developed fever and acute jaundice [bilirubin 10.8 mg/dL, ALT 77 U/L, Alk P 344 U/L], all resolving rapidly).
Shiloach E, Zecler E, Horowiz M, Scapa E. (1998). Harefuah.
Indart Pérez A, Mendia Gorostidi A, Barrio Andrés J, Arens Miravé I. (1998). Gastroenterol Hepatol. (24 year old man developed agitation and seizures after taking ecstasy, developing jaundice 3 days later [bilirubin 20.1 mg/dL, ALT 2484 U/L, Alk P 420 U/L, INR 3.9], resolving spontaneously over next 2 months).
Roques V, Perney P, Beaufort P, Hanslik B, Ramos J, Durand L, Le Bricquir Y, et al. (1998). Presse Med. (27 year old man developed weight loss and jaundice without fever after 4 years of ecstasy use, immediately after increasing use for a 15 day period [bilirubin 14.5 mg/dL, ALT 60 times ULN, Alk P 1.5 times ULN, protime 43%], resolving within 2 months of stopping use).
Giner Durán R, Flors H, Millán M, Manzanera R. (1998). Gastroenterol Hepatol. (17 year old female developed abdominal pain and jaundice one week after taking ecstasy [bilirubin 9.4 mg/dL, ALT 4080 U/L, Alk P 154 U/L, protime 65%], with resolution in 6 weeks).
Andreu V, Mas A, Bruguera M, Salmerón JM, Moreno V, Nogué S, Rodés J. (1998). Ecstasy: a common cause of severe acute hepatotoxicity. J Hepatol. (Among 62 cases of acute liver failure seen in Barcelona between 1994-1997, 5 [8%] were due to MDMA toxicity, all men, ages 17 to 20 years, with jaundice arising after 4-48 weeks of use, 7-15 days after last dose [bilirubin 21-38.9 mg/dL, ALT 2623-5282 U/L]).
Jones AL, Simpson KJ. (1999). Review article: mechanisms and management of hepatotoxicity in ecstasy(MDMA) and amphetamine intoxications. Aliment Pharmacol Ther. (Review of clinical and histological features of MDMA hepatotoxicity and possible mechanisms).
Schirren CA, Berghaus TM, Sackmann M. (1999). Thrombotic thrombocytopenic purpura after Ecstasy-induced acute liver failure. Ann Intern Med. (20 year old man developed fatigue and jaundice 1 week after ingestion of ecstasy, with subsequent acute liver failure and thrombotic thrombocytopenic purpura, ultimately responding to prednisone and plasma exchange).
Beitia G, Cobreros A, Sainz L, Cenarruzabeitia E. (2000). Ecstasy-induced toxicity in rat liver. Liver. (Toxicity of MMDA in rats is mild, but appears to be characterized by centrilobular necrosis).
Hoover-Stevens S, Kovacevic-Ristanovic R. (2000). Management of narcolepsy in pregnancy. Clin Neuropharmacol. (Review of the efficacy of medications for narcolepsy and their safety during pregnancy and breast feeding; animal studies suggest that amphetamine may be teratogenic, but there have been no adequate human studies of its safety in pregnancy).
Shibolet O, Kalish Y, Gillis S, Ilan Y. (2001). Harefuah.
Garbino J, Henry JA, Mentha G, Romand JA. (2001). Ecstasy ingestion and fulminant hepatic failure: liver transplantation to be considered as a last therapeutic option. Vet Hum Toxicol. (19 year old man took 1½ tablets of ecstasy with alcohol and developed fatigue followed by jaundice and worsening hepatic failure [ALT 336 rising to 1932 U/L, bilirubin rising to 38.2 mg/dL], followed by hepatic encephalopathy and emergency liver transplantation 31 days after the ingestion).
Lawler LP, Abraham S, Fishman EK. (2001). 3,4-Methylenedioxymethamphetamine (ecstasy)-induced hepatotoxicity: multidetector CT and pathology findings. J Comput Assist Tomogr. (24 year old woman developed jaundice 1 week after using MDMA [bilirubin 14.9 mg/dL, ALT 2215 U/L, Alk P 113 U/L], CT scans showing multiple areas of arterial enhancement which returned to near normal in follow up).
Jonas MM, Graeme-Cook FM. (2001). Case records of the Massachusetts General Hospital. Weekly clinicopathological exercises. Case 6-2001. A 17-year-old girl with marked jaundice and weight loss. N Engl J Med. (17 year old female developed jaundice after MDMA use [bilirubin 8.4 rising to 22.5 mg/dL, ALT 1236 U/L, Alk P 209 U/L], resolving in several weeks).
De Carlis L, De Gasperi A, Slim AO, Giacomoni A, Corti A, Mazza E, Di Benedetto F, et al. (2001). Liver transplantation for ecstasy-induced fulminant hepatic failure. Transplant Proc. (17 year old woman developed fatigue 6 days after taking MDMA over 10 day period [bilirubin 20 mg/dL, ALT 3040 U/L, INR 2.2], with worsening hepatic failure, undergoing liver transplantation 3 days later).
Núñez O, Bañares R, Barrio J, Menchén L, Diego A, Salinero E, Clemente G. (2002). Gastroenterol Hepatol. (Four cases of ecstasy induced liver disease: 2 women and 2 men, ages 17 to 28 years, developed jaundice 1-2 weeks after taking ecstasy [bilirubin 9.4-32 mg/dL, ALT 739-2303 U/L, Alk P 254-416 U/L, protime 15-62%], one undergoing liver transplantation 4 days after admission, the remaining 3 recovering within 2-3 months).
Lange-Brock N, Berg T, Müller AR, Fliege H, Neuhaus P, Wiedenmann B, Klapp BF, et al. (2002). Z Gastroenterol. (17 year old female developed nausea and jaundice 2 days after using ecstasy, which had been used intermittently for 6 months [bilirubin 17.3 mg/dL, ALT 2136 U/L, protime 15%], progressive hepatic failure leading to liver transplantation within 4 days).
Chaudier B, Oliver M, Coton T, Civatte M, Guisset M, Carré D, Debonne JM, et al. (2002). Gastroenterol Clin Biol. (18 year old female developed jaundice 3 weeks after taking 2 tablets of ecstasy [bilirubin 15.6 mg/dL, ALT 44 times ULN, GGT 1.4 times ULN, protime 96%], with subsequent worsening and liver biopsy showing chronic hepatitis with bridging fibrosis; one year later enzymes were normal, but repeat liver biopsy showed chronic hepatitis with mild fibrosis).
Hwang I, Daniels AM, Holtzmuller KC. (2002). "Ecstasy"-induced hepatitis in an active duty soldier. Mil Med. (21 year old man developed nausea followed by jaundice 3 days after taking 3 tablets of ecstasy, after 3 months of intermittent use [bilirubin 25 mg/dL, ALT 1,347 U/L, Alk P 118 U/L, protime 18 seconds], ultimately with spontaneous recovery).
Caballero F, Lopez-Navidad A, Cotorruelo J, Txoperena G. (2002). Ecstasy-induced brain death and acute hepatocellular failure: multiorgan donor and liver transplantation. Transplantation. (Outcome of organ transplants from two multiorgan transplant donors who died of brain death from MDMA overdose and hyponatremia; liver recipients had benign and uneventful outcomes; three cases of acute liver failure in 25, 27 and 16 year old’s with jaundice arising within days of taking ecstasy and undergoing successful emergency liver transplantation).
Carrión JA, Escorsell A, Nogué S, Mas A. (2003). Med Clin (Barc). (23 year old man taking cocaine and MDMA for 6-8 months developed fatigue and jaundice 10 days after last dose [bilirubin 33.9 mg/dL, ALT 2900 U/L, Alk P 290 U/L, protime 15%], with progressive worsening and liver transplantation, liver showing submassive necrosis).
Aknine X. (2004). Presse Med. (21 year old man with fatigue was found to have abnormal liver tests [bilirubin normal, ALT 5 times ULN, GGT normal] and history of weekend use of ecstasy for several years, enzymes becoming normal with stopping use).
Muñoz P, Drobinska A, Bianchi L, Züger Ch, Pirovino M. [Acute giant cell hepatitis in a 17-year old man]. Praxis (Bern 1994) 2004; 93: 2109-12. German. (17 year old male developed jaundice after 2-3 months of intermittent ecstasy use [bilirubin 5.6 rising to 27.5 mg/dL, ALT 1118 U/L, Alk P 480 U/L] with protracted course, resolving by 4 months; a liver biopsy showed giant cells and focal necrosis).
Salzmann J, Marie-Claire C, Noble F. (2004). Presse Med. (Review of the short- and long term toxicities of MDMA).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, 1 was attributed to cocaine; MDMA and ecstasy are not mentioned).
Liechti ME, Kunz I, Kupferschmidt H. (2005). Acute medical problems due to Ecstasy use. Case-series of emergency department visits. Swiss Med Wkly. (Retrospective analysis of 52 cases of ecstasy intoxications during 3 year period in Switzerland; collapse [37%], palpitations [19%], dizziness [15%] and anxiety [14%] or panic [31% when used with cocaine], only six required intensive care including one with hepatic failure).
Brncić N, Kraus I, Visković I, Mijandrusić-Sincić B, Vlahović-Palcevski V. (2006). 3,4-methylenedioxymethamphetamine (MDMA): an important cause of acute hepatitis. Med Sci Monit. (19 year old previously healthy man presented with jaundice 2 weeks after taking 2 tablets of ecstasy [bilirubin 7.1 rising to 15.2 mg/dL, ALT 3185 U/L, Alk P 247 U/L, GGT 135 U/L], resolving over the following 2 months).
Kis L, Pfaffenberger M. [Painless jaundice after ecstasy and alcohol consumption]. Praxis (Bern 1994) 2007; 96: 1035-7. German. (21 year old male developed painless jaundice 5 days after taking ecstasy for the first time [bilirubin 16.5 mg/dL, ALT 50 times ULN, Alk P minimally elevated], resolving over subsequent 2 months).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J. (2008). Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 3 were attributed to atomoxetine and 1 to methylphenidate, but none to amphetamines or ecstasy).
Hood B, Nowicki MJ. (2010). Eosinophilic hepatitis in an adolescent during lisdexamfetamine dimesylate treatment for ADHD. Pediatrics. (14 year old boy developed abdominal pain and jaundice 5 months after starting lisdexamfetamine [30 mg daily] for ADHD [bilirubin 9.2 mg/dL, ALT 2350 U/L], resolving within 2 months of stopping medication with prednisone therapy [later stopped]).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, including one attributed to cocaine and one to ecstasy [MDMA]).
Colak Y, Tuncer I, Enc FY, Ozturk O, Kiziltas S, Ulasoglu C. (2011). Ecstasy induced fatal hepatic failure. J Gastrointestin Liver Dis.
(19 year old man developed nausea and abdominal pain 1 week after taking MDMA [bilirubin 7.8 rising to 26.0 mg/dL, ALT 375 rising to 4555 U/L, protime “infinite”], subsequently dying of progressive hepatic failure) .
Fröhlich S, Lambe E, O'Dea J. (2011). Acute liver failure following recreational use of psychotropic "head shop" compounds. Ir J Med Sci. (28 year old man developed fever and a seizure after taking 12 tablets of a recreational amphetamine-like stimulant [butylone and methylenedioxypyrovalerone], rapidly developing shock, acute renal failure, rhabdomyolysis and liver failure [bilirubin 2.3 mg/dL, ALT 2500 U/L, CPK 112,000 U/L, INR 2.8 ], but ultimately recovering without transplantation).
Pearson JM, Hargraves TL, Hair LS, Massucci CJ, Frazee CC, Garg U, Pietak BR. (2012). Three fatal intoxications due to methylone. J Anal Toxicol. (Three cases of fatal overdose of methylone, a synthetic amphetamine also called bk-MDMA or "explosion"; deaths were due to hyperthermia, seizures and respiratory depression, but two had metabolic acidosis and one had multiorgan failure with hepatic involvement).
Kwon H, Lee SH, Kim SE, Lee JH, Jee YK, Kang HR, Park BJ, Park JW, Hong CS. (2012). Spontaneously reported hepatic adverse drug events in Korea: multicenter study. J Korean Med Sci. (Summary of 2 years of adverse event reporting in Korea; of 9360 reports, 567 were liver related, but none were attributed to amphetamines).
Payancé A, Scotto B, Perarnau JM, de Muret A, Bacq Y. (2013). Severe chronic hepatitis secondary to prolonged use of ecstasy and cocaine. Clin Res Hepatol Gastroenterol. (27 year old woman developed jaundice and ascites 9 months after starting regular use of cocaine and MDMA [bilirubin 4.5 mg/dL, ALT 220 U/L, Alk P 274 U/L], liver biopsy showing chronic hepatitis and cirrhosis, with gradual improvement upon stopping and with normal bilirubin after 2 months and normal enzymes after 10 months).
McIntyre IM, Hamm CE, Aldridge L, Nelson CL. (2013). Acute methylone intoxication in an accidental drowning--a case report. Forensic Sci Int. (19 year old woman found drowned, autopsy revealing high blood and liver methylone levels).
Pateria P, de Boer B, MacQuillan G. (2013). Liver abnormalities in drug and substance abusers. Best Pract Res Clin Gastroenterol. (Review of the liver abnormalities among drug and substance abusers and hepatotoxicity of the major abused substances, including alcohol, acetaminophen, cannabis, amphetamines, cocaine, khat and other herbals).
Vanga RR, Bal B, Olden KW. (2013). Adderall induced acute liver injury: a rare case and review of the literature. Case Rep Gastrointest Med. (55 year old woman developed acute liver injury with hepatic encephalopathy 9 months after starting amphetamine for ADHD and 5 days after increasing the dose [bilirubin 1.8 rising to 3.3 mg/dL, ALT ~5500 U/L], resolving rapidly, within 2 weeks of stopping).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, of which none were attributed to amphetamines or methylphenidate).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, but none were attributed to amphetamines).
Allen SB, Cross KP. (2014). Out of the frying pan, into the fire: a case of heat shock and its fatal complications. Pediatr Emerg Care. (15 year old male football player who was taking Adderall for ADHD collapsed during practice and on hospital admission had hyperthermia [107.3^o^F] and upon cooling and resuscitation developed hepatic, renal and respiratory failure [bilirubin not given, ALT 12 rising to 7839 U/L, Alk P 184 U/L, LDH 360 rising to 7839 U/L], dying within 4 days of multiorgan failure).
Cohen PA. (2014). Hazards of hindsight--monitoring the safety of nutritional supplements. N Engl J Med. (Commentary on the rise of reports of liver injury after use of poorly regulated nutritional supplements, some of which contain undisclosed synthetic amphetamine analogues meant to promote weight loss and boost energy levels).
Wöllner K, Stockhausen S, Mußhoff F, Madea B. (2015). Arch Kriminol. (Two fatal cases of suspected MDMA overdose: 19 year old man with rapidly fatal acute hepatic failure and a 39 year old man who collapsed at work were found to have elevated, post-mortem blood amphetamine levels).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al. (2015). United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to ecstasy [MDMA] or other amphetamines).
Atayan Y, Çağın YF, Erdoğan MA, Harputluoglu MM, Bilgic Y. (2015). Ecstasy induced acute hepatic failure. Case reports. Acta Gastroenterol Belg. (Two Turkish men, ages 24 and 18, ingested ecstasy and presented 1 week later with jaundice [bilirubin 14 and 23 mg/dL, ALT 1237 and 2154 U/L, INR 1.3 and 2.5], one developing hepatic failure and requiring transplantation and the other recovering with conservative therapy).
Maranella E, Mareri A, Nardi V, Di Natale C, Di Luca L, Conte E, Pannone V, et al. (2019). Severe neurologic and hepatic toxicity in a newborn prenatally exposed to methamphetamine. A case report. Brain Dev. (A full-term Italian newborn male with low birth weight, respiratory distress, seizures, neurologic signs and hepatomegaly had ALT 295 U/L, GGT 125 U/L, bilirubin 9.9 mg/dL and platelets of 29,000, and urine from both the child and mother tested positive for methamphetamine).
Drugs for ADHD. (2020). Med Lett Drugs Ther. (Concise review of drugs for attention deficit/hyperactivity disorder mentions that methylphenidate and the CNS stimulants are the first line agents for school age children and adolescents and that adverse events can include decreased appetite, abdominal pain, headache and insomnia, but does not mention ALT elevations or hepatotoxicity).
Zhao T, Zhai C, Song H, Wu Y, Ge C, Zhang Y, Xu H, et al. (2020). Methamphetamine-Induced Cognitive Deficits and Psychiatric Symptoms Are Associated with Serum Markers of Liver Damage. Neurotox Res. (Cognitive deficits were greater among 106 Chinese male methamphetamine-addicts at the “Compulsory Isolated Drug Rehabilitation Centre” than among 76 healthy staff members, while serum ALT levels were similar and AST levels were lower which the authors suggested was due to a “phased characteristic of liver injury”).
Patel H, Kumar K, Essrani RK, Niazi M, Makker J, Nayudu SK. (2021). Acute Hepatitis in a Yemeni Immigrant Associated with Khat: A "Biological Amphetamine" Carried in Cultures. Clin Pract. (21 year old Yemeni man developed right upper quadrant pain and liver test abnormalities [bilirubin 0.7/2.0 mg/dL, ALT 328 U/L, Alk P 78 U/L] and admitted to Khat use 5-6 times per month since moving to the US, resolving within a few months of stopping).

## OTHER REFERENCE LINKS

1 Recent References on Amphetamines: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=amphetamines+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Amphetamines: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=amphetamines)